# Ritlecitinib

## OVERVIEW

### Introduction

Ritlecitinib is an orally available small molecule inhibitor of Janus kinase 3 (JAK3) that is used to treat severe alopecia areata. Ritlecitinib is associated with a low rate of transient and usually mild elevations in serum aminotransferase levels during therapy but has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Ritlecitinib (rit" le sye' ti nib) is an orally available, specific inhibitor Janus-associated kinases (mainly irreversible inhibition of JAK3) that is used to treat moderate-to-severe alopecia areata. Alopecia areata is an autoimmune disorder that is characterized by hair loss resulting in patches and even complete baldness of the scalp, along with thinning or loss of eyebrows and eyelashes. The Janus kinases are critical steps in immune activation that transmit signals for different cytokine receptors and promote expression of genes involved in production of pro-inflammatory cytokines. JAK3, in particular, is a critical kinase in the cellular responses of interferon gamma, a cytokine found to be over-expressed in patients with alopecia areata. In multiple randomized controlled trials, ritlecitinib was found to decrease or reverse hair loss in patients with alopecia areata. Ritlecitinib was approved for this use in the United States in 2023, the 4th small molecule JAK inhibitor to receive approval, after ruxolitinib (JAK1/2 inhibitor) in 2011, tofacitinib (JAK1/3 inhibitor) in 2012, and baricitinib (JAK 1/2 inhibitor) in 2018, and the 2nd JAK inhibitor approved as therapy for alopecia areata, after baricitinib in 2022. Ritlecitinib is available in capsules of 50 mg under the brand name Litfulo (Pfizer). The recommended dose is 50 mg once daily. Current indications are severe alopecia areata (as defined by 50% hair loss or greater) in adults and adolescents 12 years and older. Common side effects are headache, dizziness, diarrhea, pyrexia, stomatitis, infections, nasopharyngitis, acne, atopic dermatitis, folliculitis, urticaria, and rash. Ritlecitinib can also cause anemia, and creatine kinase elevations. Potential severe adverse events may include reactivation of fungal, viral, and opportunistic infections such as tuberculosis, herpes simplex, and herpes zoster and malignancies. Other JAK inhibitors have been linked to a higher rate of all-cause mortality and rarely to venous and arterial thromboses and to major atherosclerotic cardiovascular and cerebrovascular events (myocardial infarction, stroke, and cardiovascular death).

### Hepatotoxicity

In the prelicensure clinical trials in alopecia areata, serum aminotransferase elevations occurred in 1% to 3% of ritlecitinib treated subjects, but similar rates were found in placebo recipients. The elevations were typically mild and transient, and values above 5 times the upper limit of normal (ULN) occurred in less than 1% of patients. The elevations rarely led to early discontinuations, and often resolved even without dose adjustment. In prelicensure studies in alopecia areata and other autoimmune conditions, there were no instances of liver related severe adverse events or clinically apparent liver injury attributed to ritlecitinib. Since approval and more widescale availability of ritlecitinib, there have been no published reports of hepatotoxicity associated with its use.

Finally, ritlecitinib is an immune modulatory agent and has the potential of causing reactivation of viral infections including hepatitis B. Other JAK inhibitors have been implicated in rare instances of reactivation of hepatitis B, although the episodes were usually asymptomatic and self-limited in course. The risk of reactivation of hepatitis B in patients with HBsAg or with anti-HBc without HBsAg who are treated with ritlecitinib has not been defined.

Likelihood score: E* (unlikely cause of idiosyncratic clinically apparent liver injury, but is a potential cause of reactivation of hepatitis B).

### Mechanism of Injury

The cause of mild serum enzyme elevations during ritlecitinib therapy is not known. Ritlecitinib is metabolized in the liver largely via CYP 3A4 and coadministration with strong inducers of CYP 3A4 should be avoided. Ritlecitinib is also an inhibitor of CYP 3A and 1A2 and can result in increases in serum levels of substrates of these two enzymes. The pharmacokinetics of ritlecitinib are not affected my mild-to-moderate liver impairment (Child-Pugh A or B), but its use is not recommended in patients with severe impairment (Child-Pugh C).

### Outcome and Management

Serum aminotransferase elevations are uncommon during ritlecitinib therapy, but routine monitoring of liver tests is recommended in the product label “according to routine patient management.” Aminotransferase elevations above 5 times the upper limit of normal (ULN) should lead to at least temporary interruption of therapy until levels fall into the normal or near normal range. Elevations above 20 times the ULN or any elevations accompanied by symptoms or jaundice should lead to permanent discontinuation.

Because of its potential to cause reactivation of hepatitis B, routine screening for HBsAg and anti-HBc before starting therapy with ritlecitinib is appropriate. Patients with HBsAg in serum should be treated prophylactically with an oral antiviral agent with activity against HBV such as entecavir or tenofovir. An alternative is to monitor patients carefully for HBV DNA levels to detect evidence of reactivation early and initiate appropriate therapy for HBV infection.

Drug Class: Dermatologic Agents, Protein Kinase Inhibitors

Other Drugs for Alopecia areata: Baricitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ritlecitinib – Litfulo®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ritlecitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ritlecitinib | 2192215-81-7 | C15-H19-N5-O

## ANNOTATED BIBLIOGRAPHY

References updated: 25 March 2024

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as tofacitinib and ritlecitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not the JAK inhibitors such as ritlecitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; ritlecitinib is not discussed).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/215830Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy mentions that there were no hepatobiliary serious adverse events, and ALT elevations led to early discontinuation in few patients but were all thought to be unrelated to therapy; the rates of serum aminotransferase elevations were not given, but there were no elevations accompanied by jaundice).
Hoisnard L, Lebrun-Vignes B, Maury S, Mahevas M, El Karoui K, Roy L, Zarour A, et al. Adverse events associated with JAK inhibitors in 126,815 reports from the WHO pharmacovigilance database. Sci Rep. 2022;12:7140. (Among 126,815 individual case safety reports on ruxolitinib, tofacitinib and baricitinib made to the WHO pharmacovigilance registry, infections were most frequent including viral, fungal, bacterial, and mycobacterial complications while there was no increase in hepatobiliary reports). 35504889
King B, Ohyama M, Kwon O, Zlotogorski A, Ko J, Mesinkovska NA, Hordinsky M, et al.; BRAVE-AA Investigators. Two phase 3 trials of baricitinib for alopecia areata. N Engl J Med. 2022;386:1687-1699. (Among 1200 patients with alopecia areata treated with baricitinib or placebo once daily for 36 weeks in two controlled trials, clinical responses were higher with 4 mg [39% and 36%] than with 2 mg [23% and 19%] or placebo [6.2% and 3.3%], while adverse event rates were similar in all 3 groups, and ALT elevations above 3 times ULN were less frequent with baricitinib than placebo [1.5% vs 2.7%]). 35334197
Shawky AM, Almalki FA, Abdalla AN, Abdelazeem AH, Gouda AM. A comprehensive overview of globally approved JAK inhibitors. Pharmaceutics. 2022;14:1001. (Review of the JAK-STAT pathways and currently approved JAK inhibitors; JAK proteins are cytoplasmic, non-receptor tyrosine kinases involved in transduction of cytokine signals that pair when binding to transmembrane cytokine receptors and, once activated, phosphorylate STAT causing its dimerization and transfer to the nucleus where it activates cytokine induced genes). 35631587
King B, Guttman-Yassky E, Peeva E, Banerjee A, Sinclair R, Pavel AB, Zhu L, et al. A phase 2a randomized, placebo-controlled study to evaluate the efficacy and safety of the oral Janus kinase inhibitors ritlecitinib and brepocitinib in alopecia areata: 24-week results. J Am Acad Dermatol. 2021;85:379-387. (Among 142 patients with alopecia areata treated with ritlecitinib or brepocitinib or placebo for 24 weeks, the alopecia severity scores improved more with the JAK inhibitors [31% and 49% vs 2%], while adverse event rates were similar in all three groups [67% and 77% vs 74%] and there were no elevations in serum ALT or AST above 2.5 times ULN in patients receiving ritlecitinib). 33757798
Ezzedine K, Peeva E, Yamaguchi Y, Cox LA, Banerjee A, Han G, Hamzavi I, et al. Efficacy and safety of oral ritlecitinib for the treatment of active nonsegmental vitiligo: a randomized phase 2b clinical trial. J Am Acad Dermatol. 2023;88:395-403. (Among 364 adults with vitiligo treated with a range of doses of ritlecitinib vs placebo for 24 weeks, vitiligo scores improved more with ritlecitinib, while adverse event rates were similar in all groups, there were no serious adverse events that resulted in drug discontinuation, and “no clinically meaningful trends in hematologic or chemical laboratory parameters were observed”). 36370907
Papierzewska M, Waśkiel-Burnat A, Rudnicka L. Safety of Janus kinase inhibitors in patients with alopecia areata: a systematic review. Clin Drug Investig. 2023;43:325-334. (Review of the safety and adverse events associated with the small molecule JAK inhibitors used to treat alopecia areata mentions that “elevated liver enzymes” arose in 5.2% of patients on ruxolitinib, 2.7% on tofacitinib, but does not provide information on baricitinib and ritlecitinib). 37138134
King B, Zhang X, Harcha WG, Szepietowski JC, Shapiro J, Lynde C, Mesinkovska NA, et al. Efficacy and safety of ritlecitinib in adults and adolescents with alopecia areata: a randomised, double-blind, multicentre, phase 2b-3 trial. Lancet. 2023;401(10387):1518-1529. (Among 718 patients with severe alopecia areata treated with one of 5 regimens of ritlecitinib or placebo for 24 weeks followed by an open label extension period of 24 weeks, “Severity of Alopecia Tool” [SALT] scores improved in higher proportions of patients on ritlecitinib [14-31%] compared to placebo [2%] and adverse event rates [total and serious] were similar in all groups; no mention of ALT elevations or hepatotoxicity). 37062298
Sandborn WJ, Danese S, Leszczyszyn J, Romatowski J, Altintas E, Peeva E, Hassan-Zahraee M, Vet al. Oral Ritlecitinib and brepocitinib for moderate-to-severe ulcerative colitis: results from a randomized, phase 2b study. Clin Gastroenterol Hepatol. 2023;21:2616-2628.e7. (Among 200 patients with moderate-to-severe ulcerative colitis treated with several doses of ritlecitinib or placebo for 8 weeks, improvements in symptom scores was greater in ritlecitinib recipients and while total adverse event rates were similar [43% vs 52%], infections occurred in 9% vs 4%, and 1 patient on ritlecitinib died of a myocardial infarction). 36623678
Blair HA. Ritlecitinib: first approval. Drugs. 2023;83:1315-1321. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of ritlecitinib shortly after its approval for treatment of alopecia areata in the US mentions that in a safety cohort of 1294 patients symptoms that were more frequent with ritlecitinib than placebo were nasopharyngitis, headache, upper respiratory tract symptoms and acne, and that herpes simplex arose in 1.3 persons per year [p/y], herpes zoster in 1.0 p/y, serious infections in 0.7 p/y and malignancies in 0.4 p/y; no mention of ALT elevations or hepatotoxicity). 37556041
Ritlecitinib (Litfulo) for severe alopecia areata. Med Lett Drugs Ther. 2023;65:185-186. (Concise summary of the mechanism of action, clinical efficacy, adverse effects, and cost of ritlecitinib shortly after its approval for use in the US mentions that the most common adverse events are headache, diarrhea, acne, rash, urticaria, folliculitis and pyrexia, and that ritlecitinib has a boxed warning that is applied to all JAK inhibitors about increased risk of serious infections, malignancies, major cardiovascular events, thromboses and death). 37983117
King B, Soung J, Tziotzios C, Rudnicka L, Joly P, Gooderham M, Sinclair R, et al. Integrated safety analysis of ritlecitinib, an oral JAK3/TEC family kinase inhibitor, for the treatment of alopecia areata from the ALLEGRO Clinical Trial Program. Am J Clin Dermatol. 2024;25:299-314. (In an analysis of cohorts of patients with alopecia areata treated with ritlecitinib [30 or 50 mg] vs placebo daily for up to 2 years, total adverse events arose in 70-75% vs 70%, serious adverse events in 0-3.2% vs 1.9% and there were no instances of drug induced liver injury or liver related severe adverse events or discontinuations; while increases in ALT to above 3 times ULN arose in 0.9-1.2% [vs none with placebo], there were no discontinuations for abnormal liver tests). 38263353

## OTHER REFERENCE LINKS

Recent References on Ritlecitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ritlecitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Ritlecitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ritlecitinib)